# Lefamulin

## OVERVIEW

### Introduction

Lefamulin is a new and relatively unique antibiotic used for treatment of community acquired pneumonia. Lefamulin has not been linked to an increased rate of transient serum liver test abnormalities during treatment or to instances of clinically apparent liver injury.

### Background

Lefamulin (le fam’ ue lin) is a relatively new semisynthetic pleuromutilin derived antibiotic that has been shown to be effective in treating uncomplicated community acquired bacterial pneumonia. Lefamulin is a systemic pleuromutilin antibiotic and is believed to act via inhibition of bacterial ribosomal RNA, blocking critical protein synthesis. Lefamulin has bactericidal activity in vitro against S. pneumoniae, H. influenzae and M. pneumoniae including macrolide resistant strains and bacteriostatic activity against S. aureus [both methicillin-sensitive and -resistant] and S. pyogenes. Lefamulin is not active against Pseudomonas aeruginosa and Enterobacter species and has not been assessed clinically for activity against methicillin-resistant Staphylococcus aureus (MRSA) infections. In pivotal trials, lefamulin given for 5 to 7 days was effective as moxifloxacin in adults with community acquired pneumonia. Lefamulin was approved for this indication in 2019. Lefamulin is available in tablets of 600 mg for oral use and in single dose vials of 150 mg in 15 mL [for intravenous use [after dilution] under the brand name Xenleta. The recommended dose of lefamulin is 600 mg orally every 12 hours for 5 days or 150 mg intravenously (over 60 minutes) every 12 hours for 5 to 7 days. Side effects are usually mild-to-moderate in severity and can include diarrhea, nausea, vomiting and headache with oral doses, and injection site reactions and hyponatremia with intravenous use. Rare, but potentially serious adverse reactions include prolongation of the QTc interval, Clostridium difficile diarrhea and embryo-fetal toxicity.

### Hepatotoxicity

Serum ALT, AST and GGT elevations above 3 times the upper limit of normal occurred in 1.2% to 3.5% of patients treated with lefamulin (n=641), but rates and severity of serum enzyme elevations were similar to those in comparator arms (moxifloxacin: n=641). These enzymes elevations were usually mild-to-moderate in severity, self-limited in duration and not accompanied by symptoms or jaundice. Instances of clinically apparent liver injury attributable to lefamulin have not been reported but this antibiotic has had limited general use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which lefamulin might cause serum aminotransferase elevations or clinically apparent liver injury is not known, but it is metabolized by the liver via the hepatic microsomal P450 system (predominantly CYP 3A4) and liver injury might be due to production of a toxic or immunogenic intermediate of its metabolism. Concurrent use of inducers or inhibitors of CYP 3A4 can affect serum levels of lefamulin. Furthermore, serum levels of other CYP 3A4 substrates can be affected by concurrent use of lefamulin, which is of particular concern for substrates that, like lefamulin, prolong the QTc interval such as moxifloxacin, erythromycin, pimozide, antipsychotics and tricyclic antidepressants.

### Outcome and Management

Serum enzyme elevations arise in a small percentage of patients being treated with lefamulin, but the course of therapy of this antibiotic is so limited that decisions to modify the dose or discontinue treatment early are unlikely to be practical or needed. Appearance of jaundice or symptoms of liver disease during therapy should lead to prompt discontinuation. There is no evidence to suggest cross sensitivity to liver injury or adverse events between lefamulin and other antibiotics.

Drug Class: Antiinfective Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lefamulin – Xenleta®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=101db63d-2fe2-48df-8506-1382d6dcd4a3)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lefamulin | 1061337-51-6 (https://pubchem.ncbi.nlm.nih.gov/substance/223370316) | C28-H45-N-O5-S

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2019

Zimmerman HJ. Antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 611-21. (Extensive review of hepatotoxicity of antibiotics published in 1999 before the availability of lefamulin).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 468-9. (Review of hepatotoxicity of antibiotics published before the availability of lefamulin).
MacDougall C. The quinolones. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1011-22. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/211672Orig1s000,%20211673Orig1s000MultidisciplineR.pdf (FDA website with product labels and reviews of safety and efficacy of drugs that were the basis for their approval: safety analysis of laboratory findings are given on pages 189-90 of the multidisciplinary review).
Paukner S, Sader HS, Ivezic-Schoenfeld Z, Jones RN. (2013). Antimicrobial activity of the pleuromutilin antibiotic BC-3781 against bacterial pathogens isolated in the SENTRY antimicrobial surveillance program in 2010. Antimicrob Agents Chemother. (Analysis of the antibacterial spectrum of lefamulin showing broad activity against most gram positive- and selected gram-negative organisms).
Eyal Z, Matzov D, Krupkin M, Paukner S, Riedl R, Rozenberg H, Zimmerman E, et al. (2016). A novel pleuromutilin antibacterial compound, its binding mode and selectivity mechanism. Sci Rep. (Analysis of the crystal structure of lefamulin suggests that it binds to the peptidyl transferase center of bacterial ribosomal RNA, but not to human rRNA, leading to inhibition of bacterial but not mammalian protein synthesis).
Veve MP, Wagner JL. (2018). Lefamulin: review of a promising novel pleuromutilin antibiotic. Pharmacotherapy. (Review of the structure, mechanism of action, spectrum of activity, clinical efficacy and safety of lefamulin, a novel antibiotic with activity against most gram positive bacteria; in discussion of safety mentions that “no clinically significant findings in any laboratory assessments… were reported”).
Wicha WW, Prince WT, Lell C, Heilmayer W, Gelone SP. (2019). Pharmacokinetics and tolerability of lefamulin following intravenous and oral dosing. J Antimicrob Chemother. (Human pharmacokinetic studies of lefamulin in 116 adults indicated that oral and intravenous dosing yielded comparable plasma levels, and side effects were mostly mild-to-moderate gastrointestinal symptoms; no mention of ALT levels or hepatotoxicity).
Alexander E, Goldberg L, Das AF, Moran GJ, Sandrock C, Gasink LB, Spera P, et al. (2019). Oral lefamulin vs moxifloxacin for early clinical response among adults with community-acquired bacterial pneumonia: the LEAP 2 randomized clinical trial. JAMA. (Among 738 adults with community acquired pneumonia treated with oral lefamulin [600 mg twice daily] or moxifloxacin [400 mg once daily] for 5 days, early clinical response rates were identical [91%], while gastrointestinal adverse events were more frequent with lefamulin including diarrhea [12% vs 1%] and nausea [5% vs 2%], but not ALT or AST elevations [0.5-0.8% vs 1.1%]).
File TM, Goldberg L, Das A, Sweeney C, Saviski J, Gelone SP, Seltzer E, et al. (2019). Efficacy and safety of iv-to-oral lefamulin, a pleuromutilin antibiotic, for treatment of community-acquired bacterial pneumonia: the phase 3 LEAP 1 trial. Clin Infect Dis. (Among 551 adults with community acquired pneumonia treated with intravenous lefamulin [150 mg every 12 hours] or moxifloxacin [400 mg every 24 hours] with option to switch to oral forms for 5-11 days, response rates were similar [87% vs 90%] as were adverse events overall [both 38%] and ALT elevations [1.8% vs 2.2%] and there were no hepatic related discontinuations or severe adverse events).
Malani PN. (2019). Lefamulin-a new antibiotic for community-acquired pneumonia. JAMA. (Editorial in response to Alexander [2019] and File [2019], two trials that led to FDA approval of lefamulin, mentions that its spectrum of activity is similar to the fluoroquinolones, but it has more gastrointestinal side effects and is more expensive).
(2019). Lefamulin (Xenleta) for community-acquired bacterial pneumonia. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of lefamulin shortly after its approval in the US; does not mention serum enzyme elevations or hepatotoxicity but concludes that less expensive, older antibiotics with a longer history of safety and efficacy are preferred for treatment of community acquired pneumonia).

## OTHER REFERENCE LINKS

1 Recent References on Lefamulin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/pubmed?cmd=search&pubmedfilters=true&term=(Lefamulin/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900/1/1%22%5bEDat%5d:%222999/12/31%22%5bEDat%5d))
2 Trials on Lefamulin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lefamulin)